# Sulfonamides

## OVERVIEW

The sulfonamides represent a large class of antibiotics that have multiple clinical uses. The sulfonamides were the first effective antibiotics to be introduced into clinical medicine and have been in use continuously since the 1930’s. They are considered bacteriostatic and appear to act by inhibition of bacterial biosynthesis of folic acid, which is needed for cell growth, at least in those bacteria that are sensitive to sulfonamides. Because humans rely upon dietary folic acid, they are usually resistant to the adverse effects of inhibition of folate synthesis. Sulfonamides have a wide range of antimicrobial activity against both gram-positive and -negative organisms. Unfortunately, bacterial resistance to sulfonamides is now common, and their use has decreased with the introduction of more potent classes of antibiotics. However, sulfonamides are still widely used especially for urinary tract infections in combination with trimethoprim and for treatment or prevention of parasitic (toxoplasmosis, pneumocystosis jiroveci) and malarial infections usually combined with trimethoprim or pyrimethamine. Sulfonamides with 5-aminosalicyclic acid are the structural components of sulfasalazine, which is widely used for long term management of inflammatory bowel disease and rheumatoid arthritis. The combination of sulfadoxine and pyrimethamine is used as prophylaxis against chloroquine-resistant malaria. Dapsone is a sulfonamide related drug that is used for the therapy of leprosy and dermatitis herpetiformis.

The sulfonamides are well known to cause idiosyncratic liver injury. Hepatotoxicity appears to be a class effect, in that virtually all sulfonamides used today have been linked to rare, but convincing cases of drug induced liver injury. The pattern of injury is variable, often mixed but it can be either hepatocellular or cholestatic. Most typically, the injury appears precipitously within one to eight weeks of starting therapy, often preceded or accompanied by signs of hypersensitivity such as fever, rash, facial edema, lymphadenopathy, arthralgias, and eosinophilia or atypical lymphocytosis (or both). Hepatotoxicity from sulfonamides may represent a part of a spectrum of hypersensitivity due to sulfa-derived medications and have been linked to many cases of DRESS (drug rash with eosinophilia and systemic symptoms) as well as Stevens Johnson syndrome and toxic epidermal necrosis. The severity of injury varies widely. Most instances of sulfonamide related liver injury are mild-to-moderate in severity and self-limited in course. Cases with severe cholestasis may be prolonged and can lead to vanishing bile duct syndrome. Importantly, sulfonamides can cause acute liver failure, particularly in instances with a precipitous onset and hepatocellular pattern of serum enzyme elevations. Indeed, the sulfonamides remain one of the most common causes of drug induced acute liver failure and account for 5% to 10% of instances in many case series.

Formulations of sulfonamides currently in general use in the United States include sulfadiazine, sulfadoxine, and sulfisoxazole as well as the combination formulations including sulfasalazine and trimethoprim-sulfamethazole (TMP-SMZ, also referred to as co-trimoxazole). The term sulfonamide applies to derivatives of para-aminobenzene sulfonamide (sulfanilamide), which is composed of a benzene ring with a sulfate and amide group at one end and an amide group at the other (para-position). These agents will be discussed largely as a groups, with the most commonly used forms and combinations dealt with individually.

Other important side effects of the sulfonamides include diarrhea, nausea, skin rash, headaches, and dizziness. Between 2% and 4% of patients have hypersensitivity responses to sulfonamides, but most of these are mild and self-limited and not associated with significant liver injury. Patients with HIV infection have higher rates of allergic reactions, but hepatotoxicity is uncommon even in this high-risk group. Rare serious side effects include severe allergic skin rashes, Stevens-Johnson syndrome, drug fever, serum sickness, agranulocytosis, aplastic anemia, nephritis, pancreatitis, confusion, ataxia and seizures. These adverse side effects can co-occur with hepatotoxicity.

Drug Class: Antiinfective Agents

The following links are to individual drug records.

1. Dapsone

2. Sulfadiazine

3. Sulfadoxine- Pyrimethamine

4. Trimethoprim-Sulfamethoxazole

5. Sulfasalazine

Other sulfonamides without separate chapters: sulfacetamide, sulfanilamide, sulfamethizine, sulfadimethoxine, sulfamethizole.

## ANNOTATED BIBLIOGRAPHY

References updated: 15 January 2026

Abbreviations: TMP-SMZ, trimethoprim and sulfamethoxazole; DRESS, drug reaction with eosinophilia and systemic symptoms; SJS, Stevens Johnson syndrome; TEN, toxic epidermal necrolysis; iv, intravenous; HLA, human leukocyte antigen.

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. The NSAIDS. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 517-41. (Expert review of the sulfonamides and sulfones published in 1999; sulfonamides are thought to cause clinically apparent liver injury in 0.5-1.0% of recipients generally with a sudden onset within 14 days of starting, often with immunoallergic features and a hepatocellular or mixed pattern of injury; mortality may be as high as 10%).
Moseley RH. Sulfonamides. Hepatotoxicity of antimicrobials and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 463-82. (Review of hepatotoxicity of antibiotics including sulfonamides).
MacDougall C. Sulfonamides, trimethoprim-sulfamethoxazole, quinolones, and agents for urinary tract infections. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1011-1021. (Textbook of pharmacology and therapeutics).
Lowe J, Smith M. The chemotherapy of leprosy in Nigeria; with an appendix on glandular fever and exfoliative dermatitis precipitated by sulfones. Int J Lepr 1949; 17: 181-95. (Summary of clinical results in using sulfones in 227 patients with leprosy described "Glandular fever and exfoliative dermatitis precipitated by sulfones" in the appendix: occurring mostly in adult men, the dermatitis in 2%, glandular fever in 12% which was marked by fever, lymphadenitis, splenomegaly and jaundice in some cases: initial description of sulfone-syndrome). 15399690
Fries J, Siragenian R. Sulfonamide hepatitis. Report of a case due to sulfamethoxazole and sulfisoxazole. N Engl J Med 1966; 274: 95-7. (60 year old woman developed jaundice after 4 days of sulfamethoxazole with fever, arthralgias and rash [bilirubin 8.4 mg/dL, ALT 360 U/L, Alk P 2.5 times ULN], with positive rechallenge within 30 hours of re-starting sulfisoxazole [AST 396 U/L, Alk P 1.5 times ULN]). 5901208
Dujovne CA, Chan CH, Zimmerman HJ. Sulfonamide hepatic injury. Review of the literature and report of a case due to sulfamethoxazole. N Engl J Med 1967; 277: 785-8. (Classic description of sulfonamide hepatotoxicity: case report of a 38 year old man who developed jaundice after 14 days of sulfamethoxazole [3rd exposure] with positive rechallenge; review of the literature on over 100 cases: usual latency of 1-4 weeks, shorter on rechallenge, rash and fever common). 6046676
Espiritu CR, Kim TS, Levine RA. Granulomatous hepatitis associated with sulfadimethoxine hypersensitivity. JAMA 1967; 202: 985-8. (24 year old man developed rash and jaundice within a week of starting sulfadimethoxine [bilirubin 4.2 mg/dL, AST 72 U/L, Alk P ~ twice ULN], liver biopsy showing granulomatous hepatitis; and rapid recovery). 5630747
Millikan LE, Harrell ER. Drug reactions to the sulfones. Arch Dermatol 1970; 102: 220-4. (50 year old man developed fever and cholestatic jaundice after a 4 week course of sulfone, resolving in a few weeks). 4914268
Das KM, Eastwood MA, McManus JP, Sircus W. Adverse reactions during salicylazosulfapyridine therapy and the relation with drug metabolism and acetylator phenotype. N Engl J Med 1973; 289: 491-5. (Slow acetylators of sulfapyridine were more likely to have side effects and high serum levels). 4146729
Frisch JM. Clinical experience with adverse reactions to trimethoprim-sulfamethoxazole. J Infect Dis 1973; 128: Suppl: 607-12 p. PMID: 4271305 (Review of post-marketing adverse event reporting on TMP-SMZ from 1968-72, 2151 reports, 32 hepatobiliary [1.5%]).
Rafoth RJ. Systemic granulomatous reaction to salicylazosulfapyridine (Azulfidine) in a patient with Crohn's disease. Am J Dig Dis 1974; 19: 465-9. (35 year old woman developed Stevens Johnson syndrome with minimal Alk P elevations, peak bilirubin 1.8 mg/dL, 19 days after starting sulfasalazine; liver and lymph node biopsies showed granulomas). 4151115
Tönder M, Nordöy A, Elgjo K. Sulfonamide-induced chronic liver disease. Scand J Gastroenterol 1974; 9: 93-6. (54 year old woman developed jaundice 4 weeks after starting TMP-SMZ [bilirubin 7.0 mg/dL, ALT 1180, Alk P twice normal], recurring with re-exposure and 1 day after a "provocation test", the injury was not really chronic as all tests were normal in follow up after stopping). 4453809
Colucci CF, Lo Cicero M. Hepatic necrosis and trimethoprim-sulfamethoxazole. JAMA 1975; 233: 952-3. Letter. PMID: 1173911 (80 year old man developed jaundice [bilirubin 10 mg/dL, ALT 135 U/L, Alk P 245 U/L] 10 days after a 10 day course of TMP-SMZ progressing to hepatic failure; massive hepatic necrosis on autopsy).
Brøckner J, Bøisen E. Fatal multisystem toxicity after co-trimoxazole. Lancet 1978; 1: 831. PMID: 85859 (63 year old man had a hypersensitivity reaction after 10 days of TMP-SMZ with multiorgan failure; liver component may have been due to shock and sepsis).
Callen JP, Soderstrom RM. Granulomatous hepatitis associated with salicylazosulfapyridine therapy. South Med J 1978; 71: 1159-60. PMID: 28568 (36 year old woman developed drug-fever on sulfasalazine with minimal ALT elevations and granulomas on liver biopsy that resolved with discontinuation of drug, follow up biopsy was normal).
Chester AC, Diamond LH, Schreiner GE. Hypersensitivity to salicylazosulfapyridine: renal and hepatic toxic reactions. Arch Intern Med 1978; 138: 1138-9. PMID: 27155 (19 year old woman developed fever, rash, eosinophilia, adenopathy and jaundice arising 3 weeks after starting sulfasalazine [bilirubin 6.5 mg/dL, AST 1060 U/L], with accompanying nephritis suggestive of DRESS syndrome, resolving after 2 weeks of prednisone).
Stevenson DK, Christie DL, Haas JE. Hepatic injury in a child caused by Trimethoprim-Sulfamethoxazole. Pediatrics 1978; 61: 864-6. (16 year old boy developed rash and fever 7 weeks after starting TMP-SMZ [bilirubin 9.4 mg/dL, ALT 294 U/L, Alk P 880 U/L, 13% eosinophils], no mention of recovery). 673549
Sotolongo RP, Neefe LI, Rudzki C, Ishak KG. Hypersensitivity reaction to sulfasalazine with severe hepatotoxicity. Gastroenterology 1978; 75: 95-9. PMID: 45581 (19 year old woman developed nausea 2 weeks after starting sulfasalazine for inflammatory bowel disease followed by fever and rash [bilirubin 0.8 rising to 5.6 mg/dL, AST 109 U/L, Alk P 322 U/L. 10% eosinophils], treated with prednisolone and recovered in 1 month).
Jacobs E, Paulet P, Rahier J. Hypersensitivity reaction to sulfasalazine--another case. Gastroenterology 1978; 75: 1193. PMID: 30678 (19 year old female with Crohn disease developed jaundice with high ALT levels, rash, fever, eosinophilia and lymphadenopathy after 8 weeks of sulfasalazine therapy, resolving within 4 weeks).
Kanner RS, Tedesco FJ, Kalser MH. Azulfidine- (sulfasalazine-) induced hepatic injury. Am J Dig Dis 1978; 23: 956-8. PMID: 31085 (13 year old girl developed fever, rash, eosinophilia, lymphadenopathy, and atypical lymphocytosis 3 weeks after starting sulfasalazine [bilirubin 4.1 mg/dL, AST 228 U/L, Alk P 149 U/L], rechallenge led to severe hepatocellular injury within 1 day).
Mihas AA, Goldenberg DJ, Slaughter RL. Sulfasalazine toxic reactions. Hepatitis, fever, and skin rash with hypocomplementemia and immune complexes. JAMA 1978; 239: 2590-1. PMID: 26816 (26 year old man developed jaundice, fever, rash, adenopathy, atypical lymphocytosis, and systemic symptoms 3 weeks after starting sulfasalazine for Crohn disease [bilirubin 1.5 mg/dL, ALT 680 U/L, Alk P 680 U/L, 12% eosinophils], resolving by 12 weeks with prednisone).
Gulley RM, Mirza A, Kelly CE. Hepatotoxicity of salicylazosulfapyridine: a case report and review of the literature. Am J Gastroenterol 1979; 72: 561-4. PMID: 43669 (20 year old woman with Crohn disease developed fever 3 weeks after starting sulfasalazine accompanied by a mixed pattern of serum enzyme elevations without jaundice and had recurrence with a similar anicteric pattern 4 days after restarting).
Iwarson S, Lundin P. Multiple attacks of jaundice associated with repeated sulfonamide treatment. Acta Med Scand 1979; 206: 219-22. (Four women, ages 20, 30, 35 and 68 years, who had repeated episodes of liver injury after sulfonamides with shortening of latency upon re-exposure, but no worsening of injury [usually hepatocellular] or slowing of resolution, which ranged from 4-12 weeks). 495230
Wormser GP, Keusch GT. Trimethoprim-sulfamethoxazole in the United States. Ann Intern Med 1979; 91: 420-9. (Review of indications, efficacy, and safety of TMP-SMZ). 382938
Nair SS, Kaplan JM, Levine LH, Geraci K. Trimethoprim-sulfamethoxazole-induced intrahepatic cholestasis. Ann Intern Med 1980; 92: 511-2. (61 year old man with cholestatic hepatitis with minimal ALT and Alk P elevations after 10 days of TMP-SMZ, resolving in 2 months). 7362156
Ogilvie AL, Toghill PJ. Cholestatic jaundice due to co-trimoxazole. Postgrad Med J 1980; 56: 202-4. (70 year old woman with severe cholestatic hepatitis with vague previous history of exposure to TMP-SMZ and prolonged exacerbation with restarting treatment before full recovery). 7393813
Abi-Mansur P, Ardiaca MC, Allam C, Shamma'a M. Trimethoprim-sulfamethoxazole-induced cholestasis. Am J Gastroenterol 1981; 76: 356-9. (52 year old woman developed jaundice within 7 days of starting TMP-SMZ [bilirubin 11.2 mg/dL, ALT 78 U/L, Alk P 210 U/L], recovery within 2 months of stopping). 7325149
Coto H, McGowan WR, Pierce EH Jr, Thomas E. Intrahepatic cholestasis due to trimethoprim-sulfamethoxazole. South Med J 1981; 74: 897-8. (55 year old man developed fever and jaundice 1 week after stopping a 2 week course of TMP-SMZ [bilirubin 7.1 mg/dL, AST 86 U/L, Alk P 1341 U/L], resolving within 6 weeks of onset). 7256343
Frey HM, Gershon AA, Borkowsky W, Bullock WE. Fatal reaction to dapsone during treatment of leprosy. Ann Intern Med 1981; 94: 777-9. (17 year old Burmese boy with suspected leprosy developed rash followed by fever and jaundice [bilirubin 7.0 mg/dL, ALT 700 U/L] 3 weeks after starting dapsone and thalidomide with atypical lymphocytosis, exfoliation, progressive liver failure, multiorgan failure, and death). 7235421
Losek JD, Werlin SL. Sulfasalazine hepatotoxicity. Am J Dis Child 1981; 135: 1070-2. (13 year old boy with Crohn disease developed fever and rash 11 days after starting sulfasalazine with subsequent marked rise in AST [1743 U/L], but normal bilirubin and rapid resolution; positive rechallenge to single dose with rash, fever and minimal ALT elevation within 1 day). 6117199
Namias A, Bhalotra R, Donowitz M. Reversible sulfasalazine-induced granulomatous hepatitis. J Clin Gastroenterol 1981; 3: 193-8. (25 year old man developed fever and jaundice [bilirubin rising to 4.0 mg/dL, ALT to ~775 U/L] 19 days after starting sulfasalazine, resolving within 6 weeks of stopping while on prednisone; liver biopsy showed granulomas). 6113258
Ransohoff DF, Jacobs G. Terminal hepatic failure following a small dose of sulfamethoxazole-trimethoprim. Gastroenterology 1981; 80: 816-9. (70 year old man, with a history of rash after taking TMP-SMZ, developed rash followed by jaundice after 2 doses of TMP-SMZ with progressive acute liver failure [bilirubin 32 rising to 44 mg/dL, AST 2390 U/L, Alk P 270 U/L] and death, autopsy showing massive necrosis). 7202951
Steinbrecher UP, Mishkin S. Sulfamethoxazole-induced hepatic injury. Dig Dis Sci 1981; 26: 756-9. (53 year old woman developed fever and arthralgias followed by jaundice 3 days after 10 day course of sulfamethoxazole with mixed enzyme pattern and recovery in ~6 weeks, recurrence with retreatment – twice). 7261840
Tomecki KJ, Catalano CJ. Dapsone hypersensitivity. The sulfone syndrome revisited. Arch Dermatol 1981; 117: 38-9. (16 year old girl developed fever and fatigue followed by jaundice beginning 2 weeks after starting dapsone [50 mg/day] for acne [bilirubin 3.6 mg/dL, ALT 560 U/L, Alk P 449 U/L, 10% eosinophils], with hemolytic anemia, responding to prednisone, and resolving within 4 weeks). 6450569
Døssing M, Andreasen PB. Drug-induced liver disease in Denmark. An analysis of 572 cases of hepatotoxicity reported to the Danish Board of Adverse Reactions to Drugs. Scand J Gastroenterol 1982; 17: 205-11. (572 reports of drug induced liver injury from 1968-78 were analyzed, representing 6% of total adverse reaction reports and 12% of those that were fatal; halothane accounted for 25% of cases, chlorpromazine 9%, sulfonamides 9%, antituberculosis agents 7%, oxyphenisatin 4%, and methyldopa 2%). 6982502
Jick H. Adverse reactions to trimethoprim-sulfamethoxazole in hospitalized patients. Rev Infect Dis 1982; 4: 426-8. (Follow up of 40,000 patients admitted to 25 Boston hospitals from 1966-80, 1,121 received TMP-SMZ, and 91 [8%] had an adverse reaction, usually gastrointestinal upset [3.7%], skin rash [3.3%], fever [0.2%], no reports of liver injury or jaundice). 6981160
Kromann NP, Vilhelmsen R, Stahl D. The dapsone syndrome. Arch Dermatol 1982; 118: 531-2. (33 year old woman developed fever and rash 2 weeks and cholestatic liver enzyme elevations [AST 241 U/L, Alk P 1341 UL, bilirubin 1.3 mg/dL, and hepatic granulomata] 4 weeks after starting dapsone, accompanied by lymphadenopathy, atypical lymphocytes and leukemoid reaction, resolving within 8 weeks of stopping). 7092282
Larcan A, Lambert H, Janot C, Perarnaud J, Delorme N, Tonnel F. [Fatal hepatitis during sulfasalazine treatment] Therapie 1982; 37: 315-9. French. PMID: 6127817 (17 year old with Crohn disease developed rash, eosinophilia, and severe hepatocellular injury with jaundice [bilirubin 3.7 mg/dL, ALT 1050 U/L, Alk P 500 U/L] 3 weeks after starting sulfasalazine, progressing to acute liver failure and death).
Lawson DH, Paice BJ. Adverse reactions to trimethoprim-sulfamethoxazole. Rev Infect Dis 1982; 4: 429-33. (Review of world’s literature on TMP-SMZ adverse drug reactions; common side effects were gastrointestinal upset and skin rash, while liver injury was rare ~2% of reported adverse events). 7051241
Olsen VV, Loft S, Christensen KD. Serious reactions during malaria prophylaxis with pyrimethamine-sulfadoxine. Lancet 1982; 2: 994. (Briefly described case of 60 year old woman traveler who developed severe jaundice after 5 weeks of pyrimethamine-sulfadoxine [Fansidar] with fever and eosinophilia, ultimately recovered). 6127497
Koch-Weser J, Hodel C, Leimer R, Styk S. Adverse reactions to pyrimethamine/sulfadoxine. Lancet 1982; 2: 1459. (Industry response to letter by Olsen [1982] stressing the safety of Fansidar; among 1.5 million exposed persons, only 24 cases of liver reactions have been reported to sponsor). 6129527
Smith MD, Gibson GE, Rowland R. Combined hepatotoxicity and neurotoxicity following sulphasalazine administration. Aust N Z J Med 1982; 12: 76-80. (Two cases of hepatocellular injury arising 3 and 5 weeks after starting sulfasalazine with rash, fever, jaundice, and neurologic signs of confusion, hallucinations, and stiff neck; rapid recovery after stopping and with prednisone therapy). 6123306
Ghishan FK. Trimethoprim-sulfamethoxazole-induced intrahepatic cholestasis. Clin Pediatr (Phila) 1983; 22: 212-4. (5 year old girl developed rash, fever, and jaundice one week after starting TMP-SMZ [bilirubin 6.5 mg/dL, ALT 44 U/L, Alk P 776 U/L], recovery within 2 weeks). 6600661
Lennard TW, Farndon JR. Sulphasalazine hepatotoxicity after 15 years’ successful treatment for ulcerative colitis. Br Med J (Clin Res Ed) 1983; 287: 96. (37 year old man with ulcerative colitis developed asymptomatic elevations in Alk P [380 U/L] and AST [49 U/L] after 15 years of sulfasalazine use, with positive rechallenge, prednisone also used and issue of sclerosing cholangitis and autoimmune hepatitis not completely addressed). 6134567
Holdsworth CD. Sulphasalazine hepatotoxicity after 15 years' treatment. Br Med J (Clin Res Ed) 1983; 287: 759. (Letter in response to Lennard [1983] discussing possibility of sclerosing cholangitis in view of presence of ulcerative colitis). 6137258
Taffet SL, Das KM. Sulfasalazine. Adverse effects and desensitization. Dig Dis Sci 1983; 28: 833-42. (Review article on adverse effects of sulfasalazine with mention of 14 case reports of liver injury, 5 with positive rechallenge, some fatal and some with granulomas). 6136396
Fich A, Schwartz J, Braverman D, Zifroni A, Rachmilewitz D. Sulfasalazine hepatotoxicity. Am J Gastroenterol 1984; 79: 401-2. (Two cases: 52 year old woman and 32 year old man with inflammatory bowel disease had hypersensitivity reactions to sulfasalazine with ALT and Alk P elevations, but no jaundice, resolving with discontinuation). 6144268
Gordin FM, Simon GL, Wofsy CB, Mills J. Adverse reactions to trimethoprim-sulfamethoxazole in patients with the acquired immunodeficiency syndrome. Ann Intern Med 1984; 100: 495-9. (Retrospective review of 38 HIV-positive patients treated with TMP-SMZ found 75% rate of dose limiting toxicity, 60% severe, and 20% had serum ALT elevations, starting within 1-2 weeks of starting). 6230976
Horák J, Mertl L, Hrabal P. Severe liver injuries due to sulfamethoxazole-trimethoprim and sulfamethoxydiazine. Hepatogastroenterology 1984; 31: 199-200. (Two case reports, 47 year old woman developed acute liver failure and died with onset of jaundice within 1 week of starting TMP-SMZ; 26 year old man developed prolonged jaundice arising 10 days after starting TMP-SMZ and slow recovery). 6510880
Thies PW, Dull WL. Trimethoprim-sulfamethoxazole-induced cholestatic hepatitis. Inadvertent rechallenge. Arch Intern Med 1984; 144: 1691-2. (54 year old man developed jaundice within 1 week of starting TMP-SMZ [bilirubin 5.0 mg/dL, ALT 255 U/L, GGT 198 U/L], resolving in 4 weeks with positive inadvertent rechallenge with 3 day latency). 6331808
Bartlett JC, Park H, Moe R. Hepatic toxicity associated with trimethoprim-sulfamethoxazole: report of a case. J Am Osteopath Assoc 1985; 85: 381-2. (67 year old developed rash, fever, and nausea within 1 week of starting TMP-SMZ, but continued drug for 4 weeks when he was found to be jaundiced with bilirubin 9.8 mg/dL, AST 150 U/L, Alk P 332 U/L). 3877712
Farr M, Symmons DP, Bacon PA. Raised serum alkaline phosphatase and aspartate transaminase levels in two rheumatoid patients treated with sulphasalazine. Ann Rheum Dis 1985; 44: 798-800. (Two women, ages 71 and 72 years, had marked Alk P elevations [745 and >2000 U/L] starting within 1 week of starting sulfasalazine for rheumatoid arthritis, without allergic manifestations, resolving slowly). 2865931
Lazar HP, Murphy RL, Phair JP. Fansidar and hepatic granulomas. Ann Intern Med 1985; 102: 722. (Two women, aged 69 and 75 years, taking sulfadoxine and pyrimethamine for prophylaxis against malaria developed fever, rash and enzyme elevations with liver biopsies showing granulomas). 3985527
Selby CD, Ladusans EJ, Smith PG. Fatal multisystemic toxicity associated with prophylaxis with pyrimethamine and sulfadoxine (Fansidar). Br Med J (Clin Res Ed) 1985; 290: 113-4. (60 year old traveler developed fever and rash 3 weeks after starting Fansidar [bilirubin rising to 22.5 mg/dL, Alk P 809 U/L, ALT 89 U/L], dying two weeks later with severe rash and renal failure). 3155635
Curley RK, Macfarlane AW. Fatal multisystemic toxicity associated with prophylaxis with pyrimethamine and sulfadoxine. Br Med J (Clin Res Ed) 1985; 290: 471-2. (Toxic epidermal necrolysis [TEN] arose after 9 days of sulfasalazine and subsequent jaundice with little information on enzymes; death appeared to be complication of TEN and corticosteroid use with herpes, septicemia, and shock). 2857586
Beard K, Belic L, Aselton P, Perera DR, Jick H. Outpatient drug-induced parenchymal liver disease requiring hospitalization. J Clin Pharmacol 1986; 26: 633-7. (Survey of a Health Management Organization admissions over 5 years identified only 12 cases of drug induced liver injury, 1 due to sulfonamides [1:6400 exposures] and one to TMP-SMZ [1:12,706 exposures]). 3793956
Haines JD Jr. Hepatotoxicity after treatment with sulfasalazine. Postgrad Med 1986; 79: 193-4, 197-8. (42 year old man with Crohn disease had onset of rash, fever, and abdominal pain 18 days after starting sulfasalazine followed by jaundice and progressive hepatic failure [ALT 3700 U/L, Alk P 619 U/L, bilirubin 18.4 mg/dL], leading to multiorgan failure and death; autopsy showed massive necrosis). 2871549
Jennings PE, Blandford RL, Rosenthal FD. Acute sulphasalazine hepatotoxicity. Postgrad Med J 1986; 62: 305-6. 2872666 (37 year old man with severe hepatocellular injury [bilirubin 6.9 mg/dL, ALT 1994 U/L, Alk P 271 U/L] starting with rash 2 weeks after starting sulfasalazine, slow to resolve).
Johnson DA, Cattau EL Jr, Kuritsky JN, Zimmerman HJ. Liver involvement in the sulfone syndrome. Arch Intern Med 1986; 146: 875-7. (49 year old woman developed fever and malaise 2 weeks after starting dapsone [bilirubin 4.5 mg/dL, AST 2540 U/L, ALk P 177 U/L]; rapid response to prednisone in ~4 weeks, review of literature and FDA reports). 3963977
Leoung GS, Mills J, Hopewell PC, Hughes W, Wofsy C. Dapsone-Trimethoprim for Pneumocystis carini pneumonia in the acquired immunodeficiency syndrome. Ann Intern Med 1986; 105: 45-8. (Experience in treating patients with known AIDS using dapsone-TMP; 6 of 15 patients had ALT elevations [peak 235 U/L] and 8 had rash, but none had jaundice). 2940954
Labadie H, Beaugrand M, Ferrier JP. [Hepatitis and mononucleosis syndrome related to the ingestion of salazosulfapyridine]. Rev Med Interne 1986; 7: 35-40. French. PMID: 2871605 (25 year old developed fever and rash 7 days after starting sulfasalazine with atypical lymphocytosis, but negative EBV testing [bilirubin 1.5 mg/dL, ALT 1035 U/L, Alk P 250 U/L]).
MacGilchrist AJ, Hunter JA. Sulphasalazine hepatotoxicity: lack of a hypersensitivity response. Ann Rheum Dis 1986; 45: 967-8. (50 year old woman with rheumatoid arthritis developed anorexia and abdominal pain 11 weeks after starting sulfasalazine; no features of hypersensitivity [bilirubin normal, ALT 1449 U/L, Alk P 230 U/L], resolving within 17 days of stopping). 2878646
Murphy RL, Phair JP. Systemic reaction to pyrimethamine-sulfadoxine. J Fam Pract 1986; 22: 375-6. (75 year old woman developed fever, rash, eosinophilia, and cholestatic liver enzymes [AST 53 U/L, Alk P 364 U/L] without jaundice after 4 weeks of pyrimethamine-sulfadoxine therapy; liver biopsy showed granulomas). 3958686
Poland GA, Love KR. Marked atypical lymphocytosis, hepatitis, and skin rash in sulfasalazine drug allergy. Am J Med 1986; 81: 707-8. (38 year old man developed rash, fever, myalgias, and facial edema with eosinophilia, atypical lymphocytosis and liver test abnormalities, within 2 weeks of starting sulfasalazine [bilirubin 2.8 mg/dL, ALT 202 U/L, Alk P 465 U/L], resolving rapidly with prednisone). 2876632
Ribe J, Benkov KJ, Thung SN, Shen SC, LeLeiko NS. Fatal massive hepatic necrosis: a probable hypersensitivity reaction to sulfasalazine. Am J Gastroenterol 1986; 81: 205-8. (15 year old boy developed severe hepatocellular injury and rash starting within 2 weeks of starting sulfasalazine, treated with prednisone and relapse of jaundice and rash when tapered; patient died of acute hemorrhage, probably from corticosteroids rather than hepatic injury). 2869683
Tanner AR. Hepatic cholestasis induced by trimethoprim. Br Med J (Clin Res Ed) 1986; 293: 1072-3. (49 year old woman developed TMP/SMZ induced cholestatic hepatitis with latency of 3 weeks and resolution in 8 weeks, developed similar pattern after five days of TMP alone). 3094778
Wejstal R, Lindberg J, Malmvall BE, Norkrans G. Liver damage associated with fansidar. Lancet 1986; 1: 854-5. (Seven cases of jaundice attributed to sulfadoxine-pyrimethamine [Fansidar] prophylaxis against malaria; cases arose after 2-12 weeks of therapy, were usually hepatocellular and 6 were jaundiced [bilirubin 0.7-15.2 mg/dL, Alk P 1-2 times normal, ALT 20-90 times normal], resolving within 4-12 weeks of stopping). 2870335
Berg PA, Daniel PT. Co-trimoxazole-induced hepatic injury--an analysis of cases with hypersensitivity-like reactions. Infection 1987; 15 Suppl 5: S259-64. (Review of hepatotoxicity of TMP-SMZ with detailed descriptions of cases in the literature). 3501774
Lawrence WA, Olsen HW, Nickles DJ. Dapsone hepatitis. Arch Intern Med 1987; 147: 175. (19 year old woman developed fever and jaundice 24 days after starting dapsone [bilirubin 9.8 mg/dL, ALT 2745 U/L, Alk P 201 U/L] with signs of acute liver failure, but ultimately spontaneous resolution). 3800520
Oliver RM, Rickenbach MA, Thomas MR, Neville E. Intrahepatic cholestasis associated with co-trimoxazole. Br J Clin Pract 1987; 41: 975-6. (65 year old man developed jaundice 4 weeks after starting TMP-SMZ therapy [bilirubin 4.5 mg/dL, AST 114 U/L, Alk P > 500 U/L], resolving within 3 months of stopping). 3509795
Zitelli BJ, Alexander J, Taylor S, Miller KD, Howrie DL, Perez TH, Van Thiel DH. Fatal hepatic necrosis due to pyrimethamine-sulfadoxine (Fansidar). Ann Intern Med 1987; 106: 393-5. (15 year old girl developed fever, rash, and jaundice after third weekly dose of pyrimethamine-sulfadoxine [bilirubin rising from 0.6 to 8.5 mg/dL, ALT 763 U/L, Alk P 669 U/L, atypical lymphocytosis]; patient ultimately died of acute liver failure). 2949680
Alberti-Flor JJ, Hernandez ME, Ferrer JP, Howell S, Jeffers L. Fulminant liver failure and pancreatitis associated with the use of sulfamethoxazole-trimethoprim. Am J Gastroenterol 1989; 84: 1577-9. (26 year old man developed acute liver failure and pancreatitis 5 days after starting TMP-SMZ while also taking 4.5 grams of acetaminophen daily, which may have contributed to the liver injury). 2596461
Coumaros D, Georges C, Zerbe S. Salicylazosulfapyridine (SASP) hepatitis: role of 5-aminosalicylic acid (5-ASA). Scand J Gastroenterol 1989; 24 (suppl 158): 132-3. Not in PubMed (26 year old woman found to have elevated ALT [5.5 times ULN] 1 year after starting sulfasalazine, not resolving until both sulfonamide and 5-ASA were stopped).
Kumar VV, Mahesh BV, Raju VK, Devi KR. Trimethoprim induced intrahepatic cholestasis. Indian Pediatr 1989; 26: 181-3. (10 year old boy developed jaundice 10 days after starting TMP-SMZ [bilirubin 8.0 mg/dL, AST 80, Alk P 5 times ULN] with rapid resolution; 3 months later a course of TMP alone led to jaundice within 1 week with similar pattern of serum enzyme elevations). 2753538
Rachmilewitz D. Coated mesalazine (5-aminosalicylic acid) versus sulphasalazine in the treatment of active ulcerative colitis: a randomised trial. BMJ 1989; 298: 82-6. (In a multicenter controlled trial of 5-ASA [mesalamine] vs sulfasalazine in 164 patients, the two agents had similar efficacy, but there were fewer hypersensitivity effects with mesalamine; nevertheless, 3% of 5-ASA treated patients developed raised ALT values and one developed hepatitis with jaundice). 2563951
Muñoz SJ, Martinez-Hernandez A, Maddrey WC. Intrahepatic cholestasis and phospholipidosis associated with the use of trimethoprim-sulfamethoxazole. Hepatology 1990; 12: 342-7. (60 year old woman developed jaundice 4 days after starting TMP-SMZ [bilirubin 20.5 mg/dL, Alk P 502 U/L, AST 188 U/L], not resolving until 6 months after stopping). 2167870
Jayalakshmi P, Ting HC. Dapsone-induced liver necrosis. Histopathology 1990; 17: 89-91. (42 year old man developed fever, rash and jaundice 6 weeks after starting dapsone for photodermatitis [bilirubin 6.8 mg/dL, ALT >500 U/L, Alk P 656 U/L, 21% eosinophils] with liver and renal failure, dying 3 days after admission, autopsy showing extensive coagulative necrosis). 2146206
Phillips-Howard PA, West LJ. Serious adverse drug reactions to pyrimethamine-sulphadoxine, pyrimethamine-dapsone and to amodiaquine in Britain. J R Soc Med 1990; 83: 82-5. (Spontaneous reporting of serious liver injury in 1:75,000 prescriptions for pyrimethamine-dapsone [Maloprim] for malaria prophylaxis in the UK). 2138674
Ramanan C, Ghorpade A, Manglani PR. Dapsone syndrome. Indian J Lepr 1991; 63: 226-8.1838381
Cockerill FR, Edson RS. Trimethoprim-sulfamethoxazole. Mayo Clin Proc 1991; 66: 1260-9. (Review of pharmacology, efficacy, and safety of TMP-SMZ). 1749295
van der Ven AJ, Koopmans PP, Vree TB, van der Meer JW. Adverse reactions to co-trimoxazole in HIV infection. Lancet 1991; 338: 431-3. (Hypothesis paper on the high rates of hypersensitivity to sulfonamides among AIDS patients). 1678095
Brooks H, Taylor HG, Nichol FE. The three week sulphasalazine syndrome. Clin Rheumatol 1992; 11: 566-8. (53 year old man with rheumatoid arthritis developed fever, rash, atypical lymphocytes, eosinophilia, and low complement levels, similar to serum sickness 2 weeks after starting sulfasalazine [bilirubin 6.0 rising to 8.9 mg/dL, ALT 231 U/L, Alk P 706 U/L], with slow recovery despite corticosteroids). 1362531
Hautekeete ML, Bourgeois N, Potvin P, Duville L, Reynaert H, Devis G, Adler M, et al. Hypersensitivity with hepatotoxicity to mesalazine after hypersensitivity to sulfasalazine. Gastroenterology 1992; 103: 1925-7. (21 year old woman developed rash 3 weeks after starting sulfasalazine, recurring 1 day after starting mesalamine [5-ASA] alone [bilirubin 2.5 mg/dL, ALT 102 U/L, Alk P 560 U/L]; went on to develop liver failure, but ultimately survived). 1360436
Kowdley KV, Keeffe EB, Fawaz KA. Prolonged cholestasis due to trimethoprim sulfamethoxazole. Gastroenterology 1992; 102: 2148-50. (Two women, ages 43 and 48 years, developed prolonged cholestasis after exposure to TMP-SMZ with latency to onset of rash of 4 days, but 2-3 weeks to onset of jaundice [bilirubin 3.6 and 27.1 mg/dL, ALT 422 and 63 U/L, Alk P 229 and 306 U/L], requiring 12 and 18 months to recover). 1587437
Friis H, Andreasen PB. Drug-induced hepatic injury: an analysis of 1100 cases reported to the Danish Committee on Adverse Drug Reactions between 1978 and 1987. J Intern Med 1992; 232: 133-8. (Adverse drug reaction reports in Denmark from 1978 to 1987; 62 cases [5%] were attributed to either TMP-SMZ or SMZ alone). 1506809
Mohle-Boetani J, Akula SK, Holodniy M, Katzenstein D, Garcia G. The sulfone syndrome in a patient receiving dapsone prophylaxis for Pneumocystis carinii pneumonia. West J Med 1992 Mar; 156: 303-6. (35 year old man with HIV and HBV infection developed fever and jaundice 6 weeks after starting dapsone prophylaxis [bilirubin 3.7 mg/dL, ALT 650 U/L, Alk P 229 U/L, 10% atypical lymphocytes], which began to resolve within days of stopping; review of 21 cases in the literature, all occurred within 2 months of starting, all with fever and most with jaundice). 1595261
Leroux JL, Ghezail M, Chertok P, Blotman F. Hypersensitivity reaction to sulfasalazine: skin rash, fever, hepatitis and activated lymphocytes. Clin Exp Rheumatol 1992; 10: 427. (45 year old woman with rheumatoid arthritis developed fever, rash, and facial edema 3 weeks after starting sulfasalazine [bilirubin not given, ALT 39 U/L, Alk P 212 U/L, eosinophils 50%], with rapid recovery upon stopping). 1356682
Reeve PA, Ala J, Hall JJ. Dapsone syndrome in Vanuatu: a high incidence during multidrug treatment (MDT) of leprosy. J Trop Med Hyg 1992; 95: 266-70. (An increase in the rate of dapsone syndrome occurred with introduction of multidrug therapy of leprosy [dapsone, clofazimine, rifampin], occurring in 24% of 37 patients and with fatality rate of 11%). 1386634
Lons T, Richardet JP, Machayekhi JP, Dalbergue B, Trinchet JC. [Granulomatous hepatitis caused by dapsone]. Gastroenterol Clin Biol 1992; 16: 293. French. PMID: 1582552 (73 year old woman developed fever and weakness 5 months after starting dapsone [bilirubin 1.8 mg/dL, ALT 3.3 times ULN, Alk P 1.6 times ULN], liver biopsy showed granulomas with giant cells, symptoms and laboratory test abnormalities resolving with stopping dapsone and increasing corticosteroids).
Malnick SD, Atali M, Israeli E, Abend Y, Geltner D. Trimethoprim/sulfamethoxazole-induced rash, fever, abnormal liver function tests, leukopenia, and thrombocytopenia. Ann Pharmacother 1993; 27: 1139-40. (54 year old woman developed rash, fever, and cytopenia with minimal ALT elevations 5 days after starting TMP-SMZ). 8219452
Carr A, Tindall B, Penny R, Cooper DA. Patterns of multiple-drug hypersensitivities in HIV-infected patients. AIDS 1993; 7: 1532-3. (Survey of 108 AIDs patients for history of allergic reactions to antibiotics, 39% reported allergy to sulfonamides, often cross reactive, but not always [dapsone vs TMP-SMZ]). 8280426
Carson JL, Strom BL, Duff A, Gupta A, Shaw M, Lundin FE, Das K. Acute liver disease associated with erythromycins, sulfonamides, and tetracyclines. Ann Intern Med 1993; 119(7 Pt 1): 576-83. (In Medicaid records between 1980-87, 107 patients were hospitalized for acute hepatitis of unknown cause, 8 had received TMP-SMZ, estimated risk from sulfonamides was <1 per 100,000 prescriptions). 8363168
Altraif I, Lilly L, Wanless IR, Heathcote J. Cholestatic liver disease with ductopenia (vanishing bile duct syndrome) after administration of clindamycin and trimethoprim-sulfamethoxazole. Am J Gastroenterol 1994; 89: 1230-4. (Two case reports; 30 year old man developed TMP-SMZ induced allergic hepatitis with jaundice evolving into a prolonged cholestatic syndrome with ductopenia). 8053440
Pickert CB, Belsha CW, Kearns GL. Multi-organ disease secondary to sulfonamide toxicity. Pediatrics 1994; 94: 237-9. (13 year old boy developed rash during 3 week course of TMP-SMZ followed 10 days later by fever and pharyngitis with eosinophilia [25%], AST 252 U/L, GGT 210 U/L, and renal failure with slow recovery). 8036081
Lindgren A, Olsson R. Liver reactions from trimethoprim. J Intern Med 1994; 236: 281-4. (Summary of Swedish adverse drug reaction reports of 21 cases of liver injury due to TMP alone; latency 5 to 24 days, all recovered, similar onset as to TMP-SMZ, but no details given). 8077884
Chalasani P, Baffoe-Bonnie H, Jurado RL. Dapsone therapy causing sulfone syndrome and lethal hepatic failure in an HIV-infected patient. South Med J 1994; 87: 1145-6. (34 year old woman with HIV infection developed rash, fever, and jaundice 1 month after starting dapsone for P. jiroveci prophylaxis [bilirubin 3.1 rising to above 20 mg/dL, AST 1186 U/L, 15% eosinophils], with subsequent progressive injury, hepatic failure and death). 7973902
Barnard GF, Scharf MJ, Dagher RK. Sulfone syndrome in a patient receiving steroids for pemphigus. Am J Gastroenterol 1994; 89: 2057-9. (66 year old man developed fever, rash, and liver test abnormalities beginning 2 weeks after starting dapsone [peak bilirubin 4 mg/dL, ALT 550 U/L, Alk P 380 U/L], resolving within 4 weeks of stopping). 7942736
Lau G. A fatal case of drug-induced multi-organ damage in a patient with Hansen's disease: dapsone syndrome or rifampicin toxicity? Forensic Sci Int 1995; 73: 109-15. (71 year old man developed jaundice 7 weeks after starting dapsone [bilirubin 23.8 mg/dL, ALT 211 U/L, Alk P 385 U/L, eosinophils 15%] with severe rash, exfoliation, multiorgan failure, and death 10 days after presentation). 7797183
Puri AS, Gupta R, Ghoshal UC, Khan E, Aggarwal R, Naik SR. Hepatic injury in sulfone syndrome: hepatitis or cholestasis? Indian J Gastroenterol 1995; 14: 20. (23 year old man developed fever, rash, and jaundice 1 month after starting triple therapy for leprosy using dapsone [bilirubin 6.8 mg/dL, ALT 187 U/L, Alk P 376 U/L, 10% eosinophils], resolving after exfoliative dermatitis within 6 weeks of stopping and later tolerating rifampin and clofazimine). 7860114
Jick H, Derby LE. A large population-based follow-up study of trimethoprim-sulfamethoxazole, trimethoprim, and cephalexin for uncommon serious drug toxicity. Pharmacotherapy 1995; 15: 428-32. (Boston database on 232,390 patients given TMP-SMZ and 266,951 given TMP alone; rates of hepatic events similar with both drugs: 3.8-5.2/100,000 exposed persons). 7479194
Simma B, Meister B, Deutsch J, et al. Fulminant hepatic failure in a child as a potential adverse effect of trimethoprim-sulphamethoxazole. Eur J Pediatr 1995; 154: 530-3. (5 year old given TMP-SMZ and then amoxicillin-clavulanate and two weeks later developed jaundice [bilirubin 20.5 mg/dL, ALT 546 U/L, Alk P 538 U/L], progressing to liver failure and need for emergency transplantation). 7556317
George DK, Crawford DH. Antibacterial-induced hepatotoxicity. Incidence, prevention and management. Drug Saf 1996; 15: 79-85. (Review of hepatotoxicity from antibiotics including sulfonamides indicating that transient increases in aminotransferase levels occur in 10% of patients, but that clinical liver injury is rare, in one study <1,100,000 prescriptions). 8862966
Prussick R, Shear NH. Dapsone hypersensitivity syndrome. J Am Acad Dermatol 1996; 35 (2 Pt 2): 346-9. (22 year old woman developed fever, rash, and lymphadenopathy 5 weeks after starting dapsone [bilirubin 3.0 mg/dL, ALT 342 U/L, Alk P 138 U/L], responding to prednisone and resolving within 6 weeks of stopping). 8698924
Pillans PI. Drug associated hepatic reactions in New Zealand: 21 years’ experience. N Z Med J 1996; 109: 315-9. (Adverse drug reaction reports identified 943 liver injuries over 21 years in New Zealand; TMP-SMZ accounted for 29 (ranking 9th), 1 case being fatal). 8816722
García Rodríguez LA, Ruigómez A, Jick H. A review of epidemiologic research on drug-induced acute liver injury using the general practice research data base in the United Kingdom. Pharmacotherapy 1997; 17: 721-8. (Review of studies of drug induced liver injury from the UK general practice database identified 23 cases of liver injury from TMP-SMZ among 232,390 users giving an incidence rate of 3.2 per 100,000 prescriptions, a rate similar to comparable antibiotics). 9250549
Cribb AE, Pohl LR, Spielberg SP, Leeder JS. Patients with delayed-onset sulfonamide hypersensitivity reactions have antibodies recognizing endoplasmic reticulum luminal proteins. J Pharmacol Exp Ther 1997; 282: 1064-71. (Comprehensive review of the major and minor side effects of sulfonamides including discussion of mechanisms). 9262376
Rieder MJ, King SM, Read S. Adverse reactions to trimethoprim-sulfamethoxazole among children with human immunodeficiency virus infection. Pediatr Infect Dis J 1997; 16: 1028-31. (Single center survey; 40% of 25 children with HIV treated with TMP-SMZ developed short latency onset allergic reactions, none with hepatic injury). 9384334
Stoschus B, Meybehm M, Spengler U, Scheurlen C, Sauerbruch T. Cholestasis associated with mesalazine therapy in a patient with Crohn's disease. J Hepatol 1997; 26: 425-8. 9059966 (30 year old man developed nausea and jaundice 4 months after starting mesalazine [5-ASA] [bilirubin 6.0 mg/dL, ALT 393 U/L, Alk P 201 U/L]; no hypersensitivity features; resolving within 6 weeks of stopping therapy).
Yao F, Behling CA, Saab S, Li S, Hart M, Lyche KD. Trimethoprim-sulfamethoxazole-induced vanishing bile duct syndrome. Am J Gastroenterol 1997; 92: 167-9. (57 year old man developed vanishing bile duct syndrome after acute hepatic injury [bilirubin 2.0 rising to 40.4 mg/dL, ALT 465 U/L, Alk P 295 U/L] arising within 1 week of starting TMP-SMZ; no allergic features; ultimately underwent liver transplantation). 8995964
Besnard M, Debray D, Durand P, Cézard JP, Navarro J. Sulfasalazine-induced fulminant hepatitis in pediatric Crohn's disease: report of two cases. J Pediatr Gastroenterol Nutr 1998; 26: 119-20. (2 cases of 10 year olds [1 boy, 1 girl] developing fever, rash, arthralgias, and eosinophilia 2-3 weeks after starting sulfasalazine, both progressing to acute liver failure). 9443132
Brett AS, Shaw SV. Simultaneous pancreatitis and hepatitis associated with trimethoprim-sulfamethoxazole. Am J Gastroenterol 1999; 94: 267-8. (34 year old woman developed fever and abdominal pain on TMP-SMZ [bilirubin 1.6 mg/dL, ALT 216 U/L, Alk P 158 U/L], resolving in 2 months; history of previous episode). 9934769
Deltenre P, Berson A, Marcellin P, Degott C, Biour M, Pessayre D. Mesalazine (5-aminosalicylic acid) induced chronic hepatitis. Gut 1999; 44: 886-8. (65 year old man developed elevated ALT levels [8-12 times ULN] without jaundice after 6 months of mesalamine therapy that continued for 10 months and was associated with autoantibodies [ANA 1:500, SMA 1:200] and chronic hepatitis on biopsy; resolved rapidly once drug was stopped). 10323894
Ilario MJ, Ruiz JE, Axiotis CA. Acute fulminant hepatic failure in a woman treated with phenytoin and trimethoprim-sulfamethoxazole. Arch Pathol Lab Med 2000; 124: 1800-3. (60 year old woman developed acute liver failure while receiving both phenytoin and TMP-SMZ). 11100060
Windecker R, Steffen J, Cascorbi I, Thürmann PA. Co-trimoxazole-induced liver and renal failure. Case report. Eur J Clin Pharmacol 2000; 56: 191-3. (48 year old man developed jaundice [bilirubin 10.2 mg/dL, ALT 723 U/L, Alk P 413 U/L], with bone marrow and renal failure 6 days after 10 day course of TMP-SMZ, ultimately recovering within 6 months). 10877016
Lau G, Kwan C, Chong SM. The 3-week sulphasalazine syndrome strikes again. Forensic Sci Int 2001; 122: 79-84. (34 year old woman developed fever, rash, and lymphadenopathy 17 days after starting sulfasalazine, with subsequent hepatocellular jaundice [bilirubin 8.9 mg/dL, ALT 10,000 U/L, Alk P 515 U/L], progressing to liver failure and death). 11672959
Kaluarachchi SI, Fernandopulle BM, Gunawardane BP. Hepatic and haematological adverse reactions associated with the use of multidrug therapy in leprosy--a five year retrospective study. Indian J Lepr 2001; 73: 121-9. (Review of side effects of multidrug therapy of leprosy in 3333 patients identified 25 cases of toxic hepatitis, usually within first 3 months of starting, some related to rifampin but details not provided). 11579648
Ransford RA, Langman MJ. Sulphasalazine and mesalazine: serious adverse reactions re-evaluated on the basis of suspected adverse reaction reports to the Committee on Safety of Medicines. Gut 2002; 51: 536-9. (Survey of adverse drug reaction reporting on 5-ASA vs sulfasalazine – UK from 1991-8 – found sulfasalazine more commonly causes liver injury ~0.6 vs 0.32/100,000 exposures). 12235076
Sgro C, Clinard F, Ouazir K, Chanay H, Allard C, Guilleminet C, Lenoir C, et al. Incidence of drug-induced hepatic injuries: a French population-based study. Hepatology 2002; 36: 451-5. (All adverse drug reactions from French region from 1997-2000 found 34 cases of liver injury, 40 drugs involved, 2 possibly due to sulfasalazine). 12143055
Mainra RR, Card SE. Trimethoprim-sulfamethoxazole-associated hepatotoxicity - part of a hypersensitivity syndrome. Can J Clin Pharmacol 2003; 10: 175-8. (24 year old woman developed fever, eosinophilia, and jaundice while taking multiple herbal medications and after a brief course of TMP-SMZ [bilirubin 10.0 mg/dL, ALT 2479 U/L, Alk P 472 U/L], severe course but ultimate recovery). 14712321
Zaman F, Ye G, Abreo KD, Latif S, Zibari GB. Successful orthotopic liver transplantation after trimethoprim-sulfamethoxazole associated fulminant liver failure. Clin Transplant 2003; 17: 461-4. (23 year old man developed liver injury arising within 7 days of starting TMP-SMZ [bilirubin rising from 0.8 to 6.9 to 10.3 mg/dL, ALT 1706 U/L], evolving rapidly into acute liver failure and need for transplant). 14703931
Itha S, Kumar A, Dhingra S, Choudhuri G. Dapsone induced cholangitis as a part of dapsone syndrome: a case report. BMC Gastroenterol 2003; 3: 21. (40 year old man developed fever, rash, and jaundice 3 weeks after starting dapsone [100 mg/day] [bilirubin 14.4 mg/dL, ALT 127 U/L, Alk P 141 U/L, 6% eosinophils], with subsequent desquamation and improvement on stopping). 12911838
Lee KB, Nashed TB. Dapsone-induced sulfone syndrome. Ann Pharmacother 2003; 37: 1044-6. (42 year old HIV-positive man developed fever, rash, and jaundice 4 weeks after starting dapsone [100 mg/day] [peak bilirubin 5.7 mg/dL, ALT 255 U/L, Alk P 2078 U/L], resolving within 8 weeks of stopping). 12841817
Halmos B, Anastopoulos HT, Schnipper LE, Ballesteros E. Extreme lymphoplasmacytosis and hepatic failure associated with sulfasalazine hypersensitivity reaction and a concurrent EBV infection--case report and review of the literature. Ann Hematol 2004; 83: 242-6. (34 year old man with Crohn disease developed fever, rash, atypical lymphocytosis, and hepatic failure after 1 day of restarting sulfasalazine, [bilirubin rising from 4.0 to 10.4 mg/dL, AST 1628 U/L, 10% eosinophilia], with apparent beneficial response to prednisone). 13680174
Karpman E, Kurzrock EA. Adverse reactions of nitrofurantoin, trimethoprim and sulfamethoxazole in children. J Urol 2004; 172: 448-53. (Review article on side effects of antibiotics used in pediatric urologic practice). 15247700
Slatore CG, Tilles SA. Sulfonamide hypersensitivity. Immunol Allergy Clin North Am 2004; 24: 477-90, vii. PMID: 15242722 (Review of mechanisms of hypersensitivity to sulfonamides).
de Abajo FJ, Montero D, Madurga M, Rodriguez LAG. Acute and clinically relevant drug-induced liver injury: a population based case-control study. Brit J Clin Pharm 2004; 58: 71-80. (Analysis of General Practice Research Database from UK on 1.6 million persons from 1994-2000 found 128 cases of drug induced liver injury [2.4/100,000 person-years]; sulfasalazine was taken by 4 of 128 cases [3%], compared to 5 of 5000 controls [adjusted odds ratio 25.5]). 15206996
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants done in the US between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, 3 of which were attributed to sulfasalazine and 1 to TMP-SMZ). 15390328
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-101. (Among 103 cases of fulminant drug induced liver injury reported to a Swedish registry between 1966 and 2002, 6 cases were attributed to TMP-SMZ, 3 to sulfonamides and 1 to sulfasalazine [~10% overall]). 16165719
Descloux E, Argaud L, Dumortier J, Scoazec JY, Boillot O, Robert D. Favourable issue of a fulminant hepatitis associated with sulfasalazine DRESS syndrome without liver transplantation. Intensive Care Med 2005; 31: 1727-8. (45 year old woman developed rash 15 days after starting sulfasalazine and subsequently developed fever, eosinophilia, and progressive liver injury leading to liver failure and death; autopsy showed massive necrosis). 16283166
Andrade RJ, Lucena MI, Fernández MC, Pelaez G, Pachkoria K, Garcia-Ruiz E, Garcia-Munoz B, et al.; Spanish Group for the Study of Drug-Induced Liver Disease. Drug-induced liver injury: an analysis of 461 incidences submitted to the Spanish registry over a 10-year period. Gastroenterology 2005; 129: 512-21. (Reports to a Spanish network between 1994-2004, included 461 cases of drug induced liver disease; sulfonamides were not mentioned in the top 19 causes [drugs with 5 or more cases]). 16083708
Garcia Rodriguez LA, Ruigomez A, Jick H. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-1101. (Among 103 cases of fulminant drug induced liver injury reported to a Swedish registry between 1966 and 2002, 6 cases were attributed to TMP-SMZ, 3 to sulfonamides and 1 to sulfasalazine [~10% overall]). 16165719
Alves-Rodrigues EN, Ribeiro LC, Silva MD, Takiuchi A, Fontes CJ. Dapsone syndrome with acute renal failure during leprosy treatment: case report. Braz J Infect Dis 2005; 9: 84-6. (39 year old woman developed fever 23 days after starting dapsone [100 mg/day] and one week later developed jaundice [direct bilirubin 1.8 mg/dL, ALT 137 U/L] and renal failure, with slow recovery on prednisone after stopping). 15947852
Abidi MH, Kozlowski JR, Ibrahim RB, Peres E. The sulfone syndrome secondary to dapsone prophylaxis in a patient undergoing unrelated hematopoietic stem cell transplantation. Hematol Oncol 2006; 24: 164-5.16639690
(51 year old woman with acute myelogenous leukemia and hematopoietic cell transplantation developed fever and hemolytic anemia followed by rash and jaundice on dapsone therapy [bilirubin 7 mg/dL, ALT 203 U/L], dying 3 weeks later) .
Björnsson E, Olsson R. Suspected drug-induced liver fatalities reported to the WHO database. Dig Liver Dis 2006; 38: 33-8. (Survey of drug induced liver fatalities reported to WHO database between 1968-2003 revealed 4690 reports – 89% from the US; 21 drugs were associated with more than 50 cases each, including TMP-SMZ [ranking 10th]). 16054882
Teo L, Tan E. Sulphasalazine-induced DRESS. Singapore Med J. 2006; 47: 237-9. (49 year old woman developed purpuric rash and eosinophilia after 4 weeks of sulfasalazine therapy accompanied by serum enzyme elevations [ALT 171 U/L, Alk P 115 U/L] but no jaundice, rapidly resolving after stopping). 16518561
Kouklakis G, Mpoumponaris A, Zezos P, Moschos J, Koulaouzidis A, Nakos A, Pehlivanidis A, et al. Cholestatic hepatitis with severe systemic reactions induced by trimethoprim-sulfamethoxazole. Ann Hepatol 2007; 6: 63-5. (30 year old man developed fever and rash 2 weeks after stopping a 15 day course of TMP-SMZ [bilirubin 2.9 mg/dL, ALT 456 U/L, Alk P 223 U/L], resolving within 3 months of onset). 17297432
Jobanputra P, Amarasena R, Maggs F, Homer D, Bowman S, Rankin E, Filer A, Raza K, Jubb R. Hepatotoxicity associated with sulfasalazine in inflammatory arthritis: A case series from a local surveillance of serious adverse events. BMC Musculoskelet Disord 2008; 9: 48. (Ten cases of sulfasalazine hepatotoxicity identified in a UK rheumatology service over 7 year period; usual onset in 2-42 days, 7 with rash, 3 eosinophilia, 5 cases in blacks, two patients required liver transplantation; estimated frequency of 4 per thousand patients exposed). 18405372
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, et al; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, 9 were due to TMP-SMZ, which ranked 4th as a cause). 18955056
Crowell CS, Melin-Aldana H, Tan TQ. Fever, rash, and hepatic dysfunction in a 3-year-old child: a case report. Clin Pediatr (Phila) 2008; 47: 517-20. (3 year old boy with rash, fever, cough, and 19% atypical lymphocytes was thought to have Kawasaki disease or mononucleosis, but later found to have received TMP-SMZ 1 week before onset [bilirubin 1.6 mg/dL, ALT 354 U/L, Alk P 351 U/L], rapid response to corticosteroids). 18509155
Jobanputra P. BSR DMARD monitoring guidelines: sulfasalazine. Rheumatology (Oxford) 2008; 47:1587-8. (Letter in response to published guidelines on sulfasalazine stressing the severe, but rare complication of hepatitis [0.4%] which can lead to acute liver failure). 18723518
Ranawaka RR, Mendis S, Weerakoon HS. Dapsone-induced haemolytic anaemia, hepatitis and agranulocytosis in a leprosy patient with normal glucose-6-phosphate-dehydrogenase activity. Lepr Rev 2008;79:436-40. (21 year old man developed fever and agranulocytosis 5 months after starting multidrug therapy of leprosy [bilirubin 2.4 mg/dL, ALT 282 U/L], which resolved within 1 month of stopping and he later tolerated long term rifampin and clofazimine therapy). 19274991
Hanses F, Zierhut S, Schölmerich J, Salzberger B, Wrede CE. Severe and long lasting cholestasis after high-dose co-trimoxazole treatment for Pneumocystis pneumonia in HIV-infected patients--a report of two cases. Int J Infect Dis 2009; 13: e467-9. (Two patients with HIV infection and pneumocystis pneumonia developed elevations in Alk P and bilirubin while on TMP-SMZ, but both also had CMV infection and multiple complications, and abnormalities persisted long term). 19299179
Sheen YS, Chu CY, Wang SH, Tsai TF. Dapsone hypersensitivity syndrome in non-leprosy patients: a retrospective study of its incidence in a tertiary referral center in Taiwan. J Dermatolog Treat 2009; 20: 340-3. (Among 361 patients without leprosy treated with dapsone over a 54 month period, hypersensitivity syndrome developed in 6 [2%], including 4 women and 2 men, arising after 8-36 days with fever and rash; 5 had liver involvement [bilirubin 1.2 to 4.7 mg/dL, ALT 62 to 1064 U/L, Alk P 297-1072 U/L], none fatal, all resolving symptomatically within 30 days). 19954390
Björnsson E, Davidsdottir L. The long-term follow-up after idiosyncratic drug-induced liver injury with jaundice. J Hepatol 2009; 50: 511-7. (Among 685 patients identified an average of 10 years after an episode of drug induced liver injury, 23 [3.4%] had continuing liver disease, 8 with cirrhosis; none were attributed to a sulfonamide). 19155082
Gutierrez M, Filippucci E, Bugatti L, Bertolazzi C, Grassi W. [Severe drug hypersensitivity syndrome due to sulphasalazine in patient with rheumatoid arthritis]. Reumatismo 2009; 61: 65-8. Italian. PMID: 19370190 (60 year old man with rheumatoid arthritis developed rash, facial edema and fever 32 days after starting sulfasalazine [bilirubin normal, ALT 74 U/L, Alk P 142 U/L, 6% eosinophils], resolution with prednisone).
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol 2010; 70: 721-8. (Worldwide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children, TMP-SMZ accounting for 48 cases [0.5%] for an adjusted odds ratio of 1.3). 21039766
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol 2010; 105: PMID: 2396-404. (313 cases of drug induced liver injury were seen over a 12 year period at a large hospital in Bangalore, India; dapsone accounted for 17 cases [5.4%] of which 2 were fatal, and TMP-SMZ accounted for 7 cases [2.2%], but none were fatal).
Lens S, Crespo G, Carrión JA, Miquel R, Navasa M. Severe acute hepatitis in the DRESS syndrome: Report of two cases. Ann Hepatol 2010; 9 (2): 198-201. (Two cases of DRESS syndrome; case 1, a 29 year old woman who developed fever, rash, eosinophilia, and jaundice 8 weeks after starting sulfasalazine [bilirubin 13.5 mg/dL, ALT 1117 U/L, Alk P 1171 U/L, INR 3.2] with signs of hepatic failure, but ultimate recovery on corticosteroids within 21 days; case 2 attributed to levetiracetam). 20526017
García-Aparicio J, Herrero-Herrero JI. [Toxic hepatitis following sequential treatment with cotrimoxazol, levofloxacin, doxycycline and sertraline in a patient with a respiratory infection]. Farm Hosp 2010; 34: 152-4. Spanish. PMID: 20471573 (65 year old woman developed jaundice shortly after having received TMP-SMZ as well as doxycycline and levofloxacin for a urinary tract infection [bilirubin 3.5 rising to 14.2 mg/dL, ALT 937 U/L, Alk P 373 U/L], resolving within 3 months of onset).
Bell TL, Foster JN, Townsend ML. Trimethoprim-sulfamethoxazole-induced hepatotoxicity in a pediatric patient. Pharmacotherapy 2010; 30: 539. (9 year old boy developed fever and abdominal pain without rash 14 days after starting a course of TMP-SMZ [bilirubin 0.6 mg/dL, ALT 624 U/L, Alk P 153 U/L, 9% eosinophils], resolving within a week of stopping). 20412003
Chisholm-Burns MA, Patanwala AE, Spivey CA. Aseptic meningitis, hemolytic anemia, hepatitis, and orthostatic hypotension in a patient treated with trimethoprim-sulfamethoxazole. Am J Health Syst Pharm 2010; 67: 123-7. (37 year old man developed fever and rash 8 days after starting TMP-SMZ [bilirubin 2.3 mg/dL, ALT 1290 U/L, Alk P not given], with hemolytic anemia, resolving in 2 weeks). 20065266
Khokhar OS, Lewis JH. Hepatotoxicity of agents used in the management of inflammatory bowel disease. Dig Dis 2010; 28: 508-18. (Review of liver toxicity of drugs for inflammatory bowel disease; sulfasalazine is cited as causing an acute hypersensitivity like reaction with fever, rash, and liver involvement, and both a granulomatous and a cholestatic form of liver injury and rarely acute liver failure). 20926880
Rogler G. Gastrointestinal and liver adverse effects of drugs used for treating IBD. Best Pract Res Clin Gastroenterol 2010; 24: 157-65. (Review of GI and liver side effects of drugs of inflammatory bowel disease; sulfasalazine is listed as causing “abnormal liver function” tests in 4% of patients). 20227029
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury including 12 due to sulfonamides [9%], 9 due to SMZ/TMP, and 3 due to sulfasalazine). Molleston JP, Fontana RJ, Lopez MJ, Kleiner DE, Gu J, Chalasani N; for the Drug-Induced Liver Injury Network. Characteristics of idiosyncratic drug-induced liver injury in children: results from the DILIN Prospective Study. J Pediatr Gastroenterol Nutr 2011; 53: 182-189. PMID: 25188760. (Among 30 children with drug induced liver injury enrolled in a prospective US database between 2004 and 2008, 15 were due to antibiotics including 1 from sulfamethoxazole). 20949552
Devarbhavi H, Karanth D, Prasanna KS, Adarsh CK, Patil M. Drug-Induced liver injury with hypersensitivity features has a better outcome: a single-center experience of 39 children and adolescents. Hepatology 2011; 54: 1344-50. (Between 1997 and 2010, 450 cases of drug induced liver injury were seen at a single center in India, including 45 cases in children [9%], among whom the most common causes were antituberculosis drugs [n=22, 50% mortality], anticonvulsants [phenytoin 10, carbamazepine 6], and dapsone 4; others included 1 case each due to TMP-SMZ, ciprofloxacin, amoxicillin and Ayurvedic agents). 21735470
Bollaert M, Jeulin H, Waton J, Gastin I, Tréchot P, Rabaud C, Schmutz JL, et al. [Six cases of spring DRESS]. Ann Dermatol Venereol 2012; 139: 15-22. French. PMID: 22225738 (Description of 6 cases of DRESS syndrome arising during a single one month period, all with reactivation of herpes virus infections [EBV, HHV-6, HHV-7 or CMV] and due to different medications, including amoxicillin, allopurinol, carbamazepine, trimethoprim-sulfamethoxazole and multiple antibiotics).
Anelli MG, Scioscia C, Grattagliano I, Lapadula G. Old and new antirheumatic drugs and the risk of hepatotoxicity. Ther Drug Monit 2012; 34: 622-8. (Review of liver injury caused by antirheumatic agents; sulfasalazine can cause liver injury in 1:1000 recipients, usually arising in the first month of treatment often with immunoallergic features and with typical signs of DRESS syndrome in some patients). 23128910
Descamps V. [Drug reaction with eosinophilia and systemic symptoms (DRESS)]. Rev Prat 2012; 62: 1347-52. French. 23424909 (Review of clinical features of DRESS syndrome in French).
Sembera S, Lammert C, Talwalkar JA, Sanderson SO, Poterucha JJ, Hay JE, Wiesner RH, et al. Frequency, clinical presentation, and outcomes of drug-induced liver injury after liver transplantation. Liver Transpl 2012; 18: 803-10. (Among 29 cases of suspected drug induced liver injury occurring in patients after liver transplantation, 11 [38%] were attributed to TMP-SMZ the mostly commonly implicated agent). 22389256
Cangemi DJ, Donovan ST, Johnson MM. 62-year-old man with painless jaundice and hyponatremia. Mayo Clin Proc 2013; 88: e49-53. (62 year old man developed jaundice shortly after 4 day course of TMP-SMZ for cellulitis [bilirubin 25.8 mg/dL, ALT 425 U/L, Alk P 1515 U/L], resolving within 3 months of onset). 23726406
Ng CT, Tan CK, Oh CC, Chang JP. Successful extracorporeal liver dialysis for the treatment of trimethoprim-sulfamethoxazole-induced fulminant hepatic failure. Singapore Med J 2013; 54: e113-6. (17 year old man developed fever and rash 28 days after starting TMP-SMZ for acne [bilirubin 3.0 rising to 19.2 mg/dL, ALT 1660 U/L, Alk P 227 U/L, eosinophils 670/μL], progressing to hepatic failure, but ultimate recovery without liver transplantation within 2 months of onset). 23716163
Pirklbauer M, Gruber J. [DRESS syndrome following sulfasalazine treatment.]. Z Rheumatol. 2014; 73(2): 180-3. German. PMID: 24337150 (33 year old woman with juvenile idiopathic arthritis developed fever, rash, and dyspnea with cough 4 weeks after starting sulfasalazine [bilirubin not given, ALT 117 U/L, GGT 422 U/L], with pulmonary manifestations of DRESS syndrome, resolving with prednisone therapy).
Girelli F, Bernardi S, Gardelli L, Bassi B, Parente G, Dubini A, Serra L, et al. A new case of DRESS syndrome induced by sulfasalazine and triggered by amoxicillin. Case Rep Rheumatol 2013; 2013: 409152. (53 year old woman developed fever and lymphadenopathy 6 weeks after starting sulfasalazine for spondylitis, with subsequent rash and oral ulcers [bilirubin 2.7 mg/dL, ALT 350 U/L, Alk P 2959 U/L], improving with prednisone therapy). 23936716
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population-based study of drug induced liver injury from Iceland, 96 cases were identified over a 2-year period, including 2 that were attributed to TMP-SMZ). 23419359
Garcia A, Yi NJ, Lee KB, Lee JM, Choi YR, Suh SW, You T, et al. Fulminant hepatitis linked to dapsone hypersensitivity syndrome requiring urgent living donor liver transplantation: a case report. Pediatr Transplant 2014; 18: E240-5. (12 year old girl developed fever and rash 3 weeks after starting dapsone, which was followed by jaundice and liver failure [bilirubin 1.8 rising to 19.6 mg/dL, ALT 131 U/L, Alk P not given, INR rising to 2.6], undergoing urgent living-donor liver transplantation, explant showing submassive necrosis). 25156688
Yang JJ, Huang CH, Liu CE, Tang HJ, Yang CJ, Lee YC, Lee KY, Tsai MS, et al. Multicenter study of trimethoprim/sulfamethoxazole-related hepatotoxicity: incidence and associated factors among HIV-infected patients treated for Pneumocystis jirovecii pneumonia. PLoS One 2014; 9: e106141. (Among 284 HIV infected patients treated with TMP-SMZ for P. jirovecii pneumonia, 152 [53%] developed liver test abnormalities which was attributed to SMP-TMP in 47 [17%] of whom 3 [1%] developed jaundice, but none died of liver failure). 25184238
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, including 39 attributed to antimicrobial agents, but none to dapsone or TMP-SMP). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 31 cases were attributed to TMP-SMZ and only 2 cases to dapsone). 25754159
Schulkes KJ, Tervaert JW, Rijken F, Haas LE. Dapsone hypersensitivity syndrome not related to G6PD deficiency. BMJ Case Rep 2015; 2015. pii: bcr2015212742. (55 year old woman developed fever, cough and rash 4 weeks after starting dapsone [bilirubin 0.9 mg/dL, ALT 150 U/L, Alk P 213 U/L, INR 1.4] with pulmonary infiltrates, resolving with prednisone therapy within 4 weeks of stopping). 26682839
Sawlani KK, Chaudhary SC, Singh J, Raja DC, Mishra S, Goel MM. Dapsone-induced pure red cell aplasia and cholestatic jaundice: A new experience for diagnosis and management. J Res Pharm Pract. 2016;5:215-8.. (30 year old woman developed jaundice and pruritus 3 months after starting dapsone for suspected dermatitis herpetiformis [bilirubin 24.3 mg/dL, ALT 345 U/L, Alk P 2840 U/L, INR 1.0] with pure red cell aplasia [Hgb 2.6 g/dL] and yet recovered spontaneously within 3 months of stopping). 27512715
Chalasani N, Reddy KRK, Fontana RJ, Barnhart H, Gu J, Hayashi PH, Ahmad J, et al. Idiosyncratic drug induced liver injury in African-Americans is associated with greater morbidity and mortality compared to Caucasians. Am J Gastroenterol 2017; 112: 1382-8. (Among 985 patients enrolled in a US prospective database of drug induced liver injury between 2004 and 2016, TMP-SMZ was the most implicated medication among 144 African Americans [7.6%], but ranked fifth among 841 Caucasians [3.6%] behind amoxicillin-clavulanate, nitrofurantoin, anabolic steroids and isoniazid). 28762375
Ferrajolo C, Verhamme KM, Trifirò G, 't Jong GW, Picelli G, Giaquinto C, Mazzaglia G, et al. Antibiotic-induced liver injury in paediatric outpatients: a case-control study in primary care databases. Drug Saf 2017; 40: 305-15. (In a case control study from a large population based database from Europe, sulfonamides were being used in 0.5% of children with new-onset, unexplained acute liver injury compared to 0.1% of controls yielding an adjusted odds ratio of 24.2). 28025733
Slim R, Asmar N, Yaghi C, Honein K, Sayegh R, Chelala D. Trimethoprim-sulfamethoxazole-induced hepatotoxicity in a renal transplant patient. Indian J Nephrol. 2017;27:482-483.. (38 year old Indian male underwent renal transplantation and was started on TMP-SMZ for prophylaxis against Pneumocystis pneumonia and was found to have abnormal liver tests without symptoms or jaundice 9 days later [bilirubin normal, ALT 375 U/L, GGT 571 U/L] which resolved rapidly resolved once TMP-SMZ was stopped]. 29217891
Sussman S, Devlin V, Dimitriades VR. A teenager with sulfasalazine-associated dress syndrome after the introduction of amoxicillin. Clin Pediatr (Phila). 2017;56:290-291. (16 year old male with ulcerative colitis developed fever and abdominal pain 3 weeks after starting sulfasalazine was treated with amoxicillin and presented with rash, lymphadenopathy, and eosinophilia [800 cells/μL] and serum aminotransferase elevations [ALT 255 U/L] without jaundice one week later, symptoms and lab tests resolving with corticosteroids). 27356629
Liang J, Qu H, Wang X, Wang A, Liu L, Tu P, Li R, Wang M. Drug reaction with eosinophilia and systemic symptoms associated with reactivation of Epstein-Barr virus and/or cytomegalovirus leading to hemophagocytic syndrome in one of two patients. Ann Dermatol. 2018;30:71-74. (Two patients, 38 year old woman and 37 year old man, developed fever followed by pruritus 4 weeks after starting sulfasalazine and 3 weeks after starting a beta lactam antibiotic with ALT 212 and 123 U/L, bilirubin 1.4 mg/dL and normal, both with evidence of Ebstein Barr Virus reactivation). 29386835
Wu X, Yang F, Chen S, Xiong H, Zhu Q, Gao X, Xing Q, et al. Clinical, viral and genetic characteristics of drug reaction with eosinophilia and systemic symptoms (DRESS) in Shanghai, China. Acta Derm Venereol. 2018;98:401-405. (Between 2011 and 2016, 52 patients were seen with DRESS syndrome at a single referral center in Shanghai, all had rash and 83% had liver test abnormalities, and 10 with EBV DNA in serum; 18 due to allopurinol, 11 sulfasalazine, and 5 carbamazepine, 3 deaths; HLA-B*13:01 in 7 of 11 sulfasalazine cases [64% vs 15% of controls] and HLA-B*58:01 in all 18 allopurinol cases [100% vs 17% of controls]). 29242946
Jeimy S, McRae K, Pattani R. A 63-year-old returned traveler with fever, rash, hepatitis and eosinophilia. CMAJ. 2018;190:E831-E835. (63 year old woman with rheumatoid arthritis developed rash and fever 1 month after starting sulfasalazine [bilirubin 0.8 rising to 3.2 mg/dL, ALT 418 U/L, Alk P 402 U/L, eosinophils 1376/μL]) 29986859
Tangamornsuksan W, Lohitnavy M. Association between HLA-B*1301 and dapsone-induced cutaneous adverse drug reactions: a systematic review and meta-analysis. JAMA Dermatol. 2018;154:441-446.. (Review of 3 studies of dapsone induced severe cutaneous adverse reactions that included appropriate controls, 86% of 111 cases vs only 13% of controls had at least one allele of HLA-B*13:01). 29541744
Casoy J, Nascimento H, Silva LMP, Fernández-Zamora Y, Muccioli C, Dias JRO, Nóbrega MJ, et al. Effectiveness of treatments for ocular toxoplasmosis. Ocul Immunol Inflamm. 2020;28:249-255.. (Among 451 Brazilian patients with ocular toxoplasmosis treated between 2013 and 2017 with either TMP-SMZ or sulfadiazine and pyrimethamine or both, successful outcomes occurred in 97% while adverse events were reported in 10% which included maculopapular rash in 4%, ALT or AST elevations in 0.4%, and Stevens Johnson syndrome in 1 patient [0.2%], no details provided). 30806556
Kathi PR, Tama M, Ehrinpreis M, Mutchnick M, Westerhoff M, Mowers J, Fontana RJ. Vanishing bile duct syndrome arising in a patient with HIV infection sequentially treated with trimethoprim/sulfamethoxazole and dapsone. Clin J Gastroenterol. 2020;13:276-280.. (58 year old African American man with HIV infection developed pruritus within 2 days and jaundice by 8 days of starting TMP-SMZ [bilirubin 11.9 mg/dL, ALT 1519 U/L, Alk P 1345 U/L] which resolved slowly after stopping but recurred 9 months later within 7 days of starting dapsone [bilirubin 16.9 mg/dL, ALT 282 U/L, Alk P 1353 U/L] which did not improve upon stopping, resulting in persistent jaundice, intractable pruritus, and liver biopsy showing vanishing bile duct syndrome resulting in hepatic failure and death 2 years later). 31317370
Siddique AS, Siddique O, Einstein M, Urtasun-Sotil E, Ligato S. Drug and herbal/dietary supplements-induced liver injury: A tertiary care center experience. World J Hepatol. 2020;12:207-219.. (Among 38 patients with suspected drug induced liver injury who presented at a single US referral center between 2013 and 2017, one was attributed to TMP-SMZ [bilirubin 10.9 mg/dL, ALT 152 U/L, Alk P 198 U/L] with macrovesicular steatosis and cholestasis on liver biopsy). 32547688
Sharma B, Antoine M, Shah M, John S. Idiosyncratic drug-induced liver injury secondary to trimethoprim-sulfamethoxazole. Am J Ther. 2020;27:e664-e667.. (44 year old woman developed nausea and abdominal pain 4 days after starting TMP-SMZ for a urinary tract infection, with rash and fever [bilirubin 0.8 rising to 2.2 mg/dL, ALT 563 rising to 6916 U/L, Alk P 100 rising to 164 U/L] with improvement on stopping TMP-SMZ and administration of N-acetyl cysteine). 31425162
Kang DY, Yun J, Lee SY, Koh YI, Sim DW, Kim S, Nam YH, et al; Korean Severe Cutaneous Adverse Reactions Consortium. A nationwide study of severe cutaneous adverse reactions based on the multicenter registry in Korea. J Allergy Clin Immunol Pract. 2021;9:929-936.e7.. (Among 745 cases of severe cutaneous adverse reactions enrolled in a Korean registry between 2010 and 2015, none of 384 cases of SJS/TEN were attributed to dapsone compared to 15 of 361 of DRESS (ranking 5^th^), but none were fatal compared to 4% of cases attributed to other causes). 32961314
Li YJ, Phillips EJ, Dellinger A, Nicoletti P, Schutte R, Li D, Ostrov DA, et al; Drug-induced Liver Injury Network. Human Leukocyte Antigen B*14:01 and B*35:01 are associated with trimethoprim-sulfamethoxazole induced liver injury. Hepatology. 2021;73:268-281.. (Among 71 patients with liver injury attributed to use of TMP-SMZ, HLA testing showed an association with HLA-B*14:01 found among 5 of 51 European Americans (AF 0.049 vs 0.009) but not African Americans among whom 5 of 10 had B*35:01 [AF 0.25 vs 0.09]) 32270503
van Asperdt JAA, De Moor RA. Aseptic meningitis, hepatitis and cholestasis induced by trimethoprim/sulfamethoxazole: a case report. BMC Pediatr. 2021;21:345.. (2.5 year old girl was hospitalized for meningitis 2 weeks after starting TMP-SMZ for otitis and developed jaundice 4 days later [bilirubin 4.4 rising to 5.8 mg/dL, ALT 358 U/L, GGT ~450 U/L] with clinical resolution and near normal values 34 days after stopping). 34399711
Huang YS, Tseng SY, Chang TE, Perng CL, Huang YH. Sulfamethoxazole-trimethoprim-induced liver injury and genetic polymorphisms of NAT2 and CYP2C9 in Taiwan. Pharmacogenet Genomics. 2021;31:200-206.. (Among 158 Han Chinese patients seen at Taipei Veterans General Hospital between 2003 and 2010 with suspected TMP-SMZ hepatotoxicity, slow NAT2 acetylation status was more frequent in patients than in 145 controls who tolerated therapy [42% vs 26%], with no clear association with age, latency, or clinical features. 34149005
Sil A, Bhattacharjee MS, Chandra A, Pramanik JD. Sulfasalazine-induced drug reaction with eosinophilia and systemic symptoms (DRESS) with concomitant acute chikungunya virus infection: possible role of new viral trigger. BMJ Case Rep. 2021;14:e244063. (30 year old Indian man developed fever and rash 2 months after starting sulfasalazine for joint pain was thought to have chikungunya virus infection but developed facial edema and lymphadenopathy with leukocytosis and eosinophilia [21%] and ALT elevation [190 U/L] and was treated with prednisone for suspected DRESS syndrome with gradual response and no relapse when corticosteroids were stopped). 34642219
Jayachandran M, Koshy V, David R, Santhakumari V, Padmanabhan DS, Surendran S, Tiwari A, et al. Adverse reaction profile of sulfasalazine and its persistence in chronic therapy of rheumatoid arthritis and spondyloarthritis: A multicentric observational study. Int J Clin Pharmacol Ther. 2022;60:327-335.. (Among 1114 patients with rheumatoid arthritis or spondyloarthritis being treated with sulfasalazine in one of 6 centers across India, 10% discontinued therapy because of adverse events including liver injury, usually during the first year of therapy: Abstract only). 35713159
Hindosh N, Kotala R, Nguyen K, Pintor A. Trimethoprim-sulfamethoxazole-induced drug reaction with eosinophilia and systemic symptoms (DRESS) complicated by acute liver failure. Cureus. 2022;14:e30852.. (57 year old Asian American man developed fatigue, fever, and rash 2 weeks after finishing a 2 week course of TMP-SMZ [bilirubin 20.5 mg/dL, ALT 376 U/L, Alk P 1476 U/L, INR 1.2, eosinophils 29%, and platelet count of 1,000/μL], improving after intravenous methylprednisolone but with slow recovery] 36457619
Kuchinskaya EM, Chikova IA, Kostik MM. Case report: sulfasalazine-induced hypersensitivity. Front Med (Lausanne). 2023;10:1140339. (12 year old girl with juvenile idiopathic arthritis developed fever and rash 17 days after starting sulfasalazine [bilirubin not given, ALT 150 rising to 1436 U/L, Alk P not given, eosinophil count not given] with leukocytosis, atypical lymphocytes, thrombocytopenia and ascites, responding to high dose methylprednisolone and subsequent gradual taper). 37293296
Fontana RJ, Kleiner DE, Chalasani N, Bonkovsky H, Gu J, Barnhart H, Li YJ, et al. The impact of patient age and corticosteroids in patients with sulfonamide hepatotoxicity. Am J Gastroenterol. 2023;118:1566-1575.. (Among 105 cases of sulfonamide-induced liver injury enrolled in a prospective U.S. database between 2004 and 2020, 93 were due to trimethoprim-sulfamethoxazole, 9 to sulfasalazine, 2 to dapsone and 1 to sulfadiazine; the 93 cases due to TMP- SMZ had a median age of 46 years, 52% were female, 76% white and 17% black, 82% were jaundiced with mean bilirubin of 4.3 mg/dL, ALT of 388 U/L, and Alk P of 258 U/L], 40% were severe and 4% fatal or transplanted within 6 months; the proportion of patients with cholestatic injury increased with age while the proportion with hepatocellular injury decreased; a weak association with HLA-B*14:01 was found in Whites (carrier rate 16%] and with HLA-B*35:01 in Blacks). 36848311
Sircar S, Rayan M, Okonoboh P. TMP-SMX induced type 4 hypersensitivity with multi-organ involvement. ID Cases. 2023;34:e01917.. (61 year old man developed fever, rash, and confusion 2 weeks after stopping a one-week course of TMP-SMZ [bilirubin 0.6 mg/dL, ALT 79 rising to 214 U/L, Alk P not given, INR 1.1, creatinine 2.8 mg/dL, platelets 13,000/μL] responding to supportive care and blood test results improving on discharge 5 days later). 37954169
Wung CH, Wang CW, Lai KC, Chen CB, Chen WT, Hung SI, Chung WH; Taiwan Severe Cutaneous Adverse Reaction Consortium. Current understanding of genetic associations with delayed hypersensitivity reactions induced by antibiotics and anti-osteoporotic drugs. Front Pharmacol. 2023;14:1183491.. (Review of the literature on the HLA associations associated with severe cutaneous adverse reactions mentions that HLA-B*13:01 is a strong risk factor for both SJS and DRESS syndrome due to dapsone in Asian populations). 37180708
Alhusari L, Pigliacampi M, Alshawabkeh Y, Hamdani T, Bsiso T, Mustafa B, Dial L. Dapsone-induced methemoglobinemia presenting concomitantly with COVID-19 pneumonia and pulmonary embolism: a case report. Cureus. 2024;16:e51830.. (A 73 year old man with bullous pemphigoid treated with dapsone developed severe respiratory failure due to COVID-19 infection and pneumonia and was found to have methemoglobinemia, no mention of liver injury or ALT levels). 38327942
Kato H, Hagihara M, Asai N, Mikamo H, Iwamoto T. Evaluation of effectiveness, hyperkalaemia, and hepatotoxicity of trimethoprim-sulphamethoxazole prophylaxis for Pneumocystis jirovecii pneumonia in paediatric patients: A single-centre retrospective study. Int J Antimicrob Agents. 2024;63:107151.. (Among 215 children with HIV infection seen at a single Japanese referral center between 2018 and 2023, who were given prophylaxis against Pneumocystis jirovecii pneumonia with TMP-SMZ, no child developed pneumocystis pneumonia but 34 [16%] developed hepatotoxicity; no information given about severity, jaundice, hospitalizations, or outcomes). 38508538
Torgersen J, Mezochow AK, Newcomb CW, Carbonari DM, Hennessy S, Rentsch CT, Park LS, et al. Severe acute liver injury after hepatotoxic medication initiation in real-world data. JAMA Intern Med. 2024;184:943-952.. (Analysis of the US Veterans Administration electronic health records between 1999 and 2021 identified 1739 hospitalizations for acute liver injury suspected to be due to medications including 32 attributed to SMZ for an estimated incidence rate of 1 per 1960 patients exposed). 38913369
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102.. (Among 483 cases of drug-induced liver injury enrolled in a prospective Latin American database, only 3 were attributed to TMP-SMZ, 3 to sulfadiazine, 2 to dapsone, and one to sulfasalazine). 38992407
Chen VL, Rockey DC, Bjornsson ES, Barnhart H, Hoofnagle JH; Drug-Induced Liver Injury Network Investigators. Incidence of idiosyncratic drug-induced liver Injury caused by prescription drugs. Drug Saf. 2025;48:151-160.. (Analysis of 1284 cases of drug-induced liver injury enrolled in a U.S. prospective study, identified 75 cases [6%] attributed to TMP-SMZ making it the second most frequently implicated drug, occurring at an estimated rate of 1 per 4,900 persons treated; and 11 cases [6%] to sulfasalazine at an estimated rate of 1 per 820 persons treated). 39317916
Lammert C, Teal E, Ghabril M, Chalasani N. Incidence of possible drug-induced liver injury due to commonly implicated agents in the United States. Clin Gastroenterol Hepatol. 2025;23:1061-1062.e1.. (Analysis of a health database of 16 Indiana University Health hospitals between 2017 and 2022, identified 54 cases of drug-induced liver injury to commonly implicated agents such as azithromycin [15 cases], amoxicillin-clavulanate [8], levofloxacin [7], and ciprofloxacin [6); but none were attributed to TMP-SMZ, despite 10,161 persons exposed). 39447947
Björnsson RA, Sigurdsson SS, Arnarson DT, Logason E, Björnsson ES. The frequency of drug-induced liver injury due to antibiotics among hospitalised patients. Drug Saf. 2025;48:795-804.. (Among 2292 patients treated with the 14 most used antibiotics while hospitalized in a single Icelandic referral center between 2012-2023, 52 developed evidence of drug-induced liver injury including 3 attributed to TMP-SMZ for an estimated rate of one per 1096 patients exposed). 40072769
Karna NK, Osti A, Pokhrel G, Karna N, Thakur RK, Sigdel S. Concurrent acute interstitial nephritis with acute pyelonephritis in DRESS syndrome: a rare case report. Ann Med Surg (Lond). 2025;87:3925-3930. (19 year old Nepalese woman developed fever, rash, and facial edema 2 months after starting sulfasalazine for back pain and TMP-SMZ for urinary tract infections [peak bilirubin 2.3 mg/dL, ALT 1306 U/L, Alk P 196 U/L, eosinophilia 11%, serum albumin 2.0 g/dL, proteinuria 4 g/24 hours] responding to high dose methylprednisolone and tapering doses of corticosteroids with ultimate resolution of both the liver and renal abnormalities). 40486566
Andrews MB, Patrone MV, Bickston SJ. Drug reaction with eosinophilia and systemic symptoms (dress) syndrome following initiation of sulfasalazine for ulcerative colitis: a yearlong clinical challenge. Case Rep Gastrointest Med. 2025;2025:8870613.. (34 year old African American woman with ulcerative colitis developed fever, generalized rash, facial edema, and lymphadenopathy 5 weeks after starting sulfasalazine [bilirubin 2.0 mg/dL, ALT 641 rising to 1847 U/L, Alk P 214 to 265 U/L, INR peak 1.8, peak eosinophils 3000/μL] responding to prednisone and cyclosporin but requiring high doses and relapsing repeatedly when drugs were tapered until 1 year after onset when she finally tolerated withdrawal without relapse). 40546655
Rahnama-Moghadam S, Arora N, Vuppalanchi R, Li YJ, Gu J, Barnhart H, Phillips E, Chalasani N; Drug Induced Liver Injury Network. DRESS syndrome in patients with drug-induced liver injury: characteristics and high-risk factors. Am J Gastroenterol. 2025 Jun 12:10. Epub ahead of print.. (Among 2121 patients with suspected drug-induced liver injury enrolled in a prospective US registry between 2004 and 2023, 105 were attributed to TMP-SMZ including 20 [19%] with drug-reaction with eosinophilia and systemic symptoms [DRESS] and another 23 [22%] with rash without DRESS). 40504263
Hishinuma M, Hasegawa M, Minatoguchi S, Umeda R, Koide S, Hayashi H, Yuzawa Y, et al. A case of vanishing bile duct syndrome caused by a treatment regimen including avacopan for microscopic polyangiitis. Intern Med. 2025 Sep 11. Epub ahead of print.. (81 year old man with vasculitis developed jaundice 42 days after starting rituximab, prednisolone, avacopan, and prophylaxis with TMP-SMZ [bilirubin 3.1 rising to 35 mg/dL, ALT 274 U/L, Alk P 402 U/L] with progressive cholestasis and liver biopsy showing vanishing bile duct syndrome, which was attributed to avacopan and which led to liver failure and death within 3 months of onset). 40930823
Casado FC, Samper AD. Sulfonamide allergy and alternative treatments in ocular toxoplasmosis. Rom J Ophthalmol. 2025;69:147-157. (The first line therapy of ocular toxoplasmosis is either TMP-SMZ or pyrimethamine-sulfadiazine but for the 3% to 8% of patients who are allergic to sulfonamides, alternatives include clindamycin or azithromycin both of which are similarly effective). 40698108
West W 3rd, Buller KT, McArthur M, Wright B, Bodnar M, Marek JC, Smith DJ, et al. a retrospective review of silver sulfadiazine use in patients with sulfa-allergic burns at a regional burn center. Cureus. 2025;17:e84360. (Among 71 patients cared for in a referral burn center who gave a history of sulfa allergy but were nevertheless treated with topical silver sulfadiazine for burn management, none suffered an allergic local or systemic reaction). 40535410
Ali N, Abughazal M, Honeini R, Honeini R. Recognizing drug-induced methemoglobinemia in the emergency setting: a case of topical dapsone toxicity. Cureus. 2025;17:e92342.. (21 year old woman with acne taking topical dapsone for 6 months developed headaches and shortness of breath and was found to have hypoxia and methemoglobinemia which resolved with stopping the cream, no mention of ALT or hepatoxicity). 41103871

## OTHER REFERENCE LINKS

1. Recent References on Sulfonamides: from PubMed.gov (https://pubmed.ncbi.nlm.nih.gov/?cmd=search&pubmedfilters=true&term=(sulfonamides%20AND%20anti-bacterial%20agents)%20AND%20Human%5bMesh%5d%20AND%20(jaundice%20OR%20bile%20duct%20diseases%20OR%20liver%20OR%20liver%20diseases%20OR%20hepatitis,%20toxic%5bMesh%5d)%20AND%20(%222009/1/1%22%5bEDat%5d:%222999/12/31%22%5bEDat%5d))

2. Trials on Sulfonamides: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=sulfonamides)